# Hydralazine

## OVERVIEW

### Introduction

Hydralazine is a commonly used oral antihypertensive agent that acts by inducing peripheral vasodilation. Hydralazine has been linked to several forms of acute liver injury as well as a lupus-like syndrome.

### Background

Hydralazine (hye dral' a zeen) is a phthalazine derivative and antihypertensive agent which acts by direct relaxation of arteriolar smooth muscle, probably by alteration in intracellular calcium signaling. Hydralazine was one of the first oral antihypertensive medications introduced into clinical medicine and was first used in the late 1950s, but was officially approved for use in the United States in 1984. The vasodilation caused by hydralazine is followed by reflex sympathetic response that may partially reverse its antihypertensive effects. Nevertheless, when combined with other antihypertensive medications, hydralazine is effective in lowering blood pressure and it is still widely used, with more than 2 million prescriptions for hydralazine being filled yearly in the United States. Hydralazine is available in generic forms and under the brand name of Apresoline in tablets of 10, 25, 50 and 100 mg as well as in parenteral forms. The typical dose is 10 mg four times daily initially, with subsequent increases to a maximum of 200 mg daily. Common side effects include dizziness, headache, tachycardia, orthostatic hypotension, flushing, nausea and gastrointestinal upset.

### Hepatotoxicity

Serum aminotransferase elevations during hydralazine therapy are considered uncommon. However, hydralazine has been clearly linked to cases of acute liver injury with jaundice as well as a delayed lupus-like syndrome. Two clinical patterns of hepatic injury have been described, associated with either a short (2 to 6 weeks) or long (2 months to more than a year) latency period. The clinically apparent liver injury is usually hepatocellular, although cholestatic forms have also been reported (Case 1). In cases with a short latency period, rash, fever and eosinophilia are common and the onset is typically abrupt and severe, and recovery is rapid. In cases with a longer latency (Case 2), the onset is more typically insidious, liver biopsy may resemble chronic hepatitis and demonstrate fibrosis, and autoantibodies are often present. The late form of hepatitis may also accompany the lupus-like syndrome that occurs with hydralazine, particularly in high doses when given for 6 months or more. Recovery can be prolonged. Autoantibodies to isoforms of the P450 system (CYP 1A2) have been identified in patients with hepatotoxicity due to the structurally related antihypertensive agent dihydralazine (available in Europe, but not the United States) and which is associated with a higher rate of hepatotoxicity than hydralazine.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the acute liver injury due to hydralazine appears to be due to its metabolism to an immunologic adduct that can result in an immunoallergic hepatitis or a more delayed lupus- and/or an autoimmune hepatitis-like syndrome. Hydralazine, like isoniazid, is metabolized by N-acetyltransferase (NAT) and hepatic injury may be more frequent with specific genetic variants in NAT activity.

### Outcome and Management

Fatal instances of liver injury due to hydralazine have been reported, but most cases begin to resolve within a few days of stopping the medication. In patients with signs and symptoms of hypersensitivity, corticosteroids are often used and anecdotal results suggest that they are beneficial in speeding recovery. The duration of therapy with corticosteroids, however, should be kept to a minimum and careful follow up after stopping is prudent. While liver histology can resemble chronic hepatitis and include hepatic fibrosis, persistent injury and vanishing bile duct syndrome have not been reported after hydralazine induced liver injury. Reexposure to hydralazine results in prompt recurrence, that can be severe. There does not appear to be cross reactivity of hepatic injury with other medications or antihypertensive agents, but there may be cross reactivity to other phthalazines such as dihydralazine and possibly to isoniazid.

Drug Class: Antihypertensive Agents

## CASE REPORTS

### Case 1. Rapid onset of acute cholestatic hepatitis due to hydralazine.

[Modified from: Myers JI, Augur NA. Hydralazine-induced cholangitis. Gastroenterology 1984; 87: 1185-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6479540)]

A 59 year old woman with coronary artery disease and hypertension was started on hydralazine and developed fever, malaise, and right upper quadrant pain 8 days later. She was admitted for suspected cholecystitis, but ultrasound of the abdomen showed no abnormalities of the biliary system. She had no history of alcohol abuse or liver disease and was known to have normal liver tests in the past. On admission, she had leukocytosis, the total serum bilirubin was 5.2 mg/dL, alkaline phosphatase 540 U/L and AST 141 U/L (Table). Hydralazine was stopped and she recovered rapidly. After discharge, she restarted hydralazine on her own and rapidly developed symptoms again with nausea, vomiting, fever and hypotension. She was febrile and jaundiced, but had no rash or eosinophilia. Autoantibodies were negative. She underwent exploratory laparotomy which was unrevealing; the gallbladder was removed but there were no stones and no biliary dilatation by intraoperative cholangiography. A liver biopsy showed intrahepatic cholestasis. She recovered rapidly and three months later, when readmitted for coronary artery bypass surgery, her liver tests were back to baseline values.

#### Key Points

Medication: | Hydralazine
Pattern: | Cholestatic (R=1.1)
Severity: | Moderate (3+; jaundice and hospitalization)
Latency: | 8 days; 2 days on rechallenge
Recovery: | Within 1-3 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 41 | 145 | 0.7
Developed fever and right upper quadrant pain 8 days after starting hydralazine
8 days | 0 | 141 | 540 | 5.2 | US normal
14 days | 4 days | 48 | 141 | 1.7
Unintentional rechallenge with hydralazine for 1-2 days
24 (1 day) | 0 | 92 | 244 | 3.5 | Cholecystectomy
35 (11) days | 10 days | 53 | 237 | 0.7
3 months | 3 months | 23 | 127 | 0.6
Normal Values | | <50 | <115 | <1.2

#### Comment

An example of hydralazine induced liver injury with a short latency (8 days), mild immunoallergic features (fever) and a cholestatic pattern of liver enzymes. She had immediate recurrence of injury on mistakenly restarting the drug. Patients with drug induced liver injury should be specifically warned about restarting the medication and should specifically search out and discard any residual medication that might still be in home medicine cabinets. The recurrence of jaundice was interpreted as cholecystitis and she underwent an unnecessary cholecystetomy. This example demonstrates how early and accurate diagnosis of drug induced liver injury can help avoid unnecessary, invasive diagnostic or therapeutic interventions.

### Case 2. Cholestatic hepatitis due to hydralazine with delayed onset.

[Modified from: Hassan A, Hammad R, Cucco R, Niranjan S. Hydralazine-induced cholestatic hepatitis. Am J Ther 2009; 16: 371-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/19092641)]

A 63 year old woman with hypertension and end-stage renal disease on dialysis developed epigastric pain and jaundice approximately 12 weeks after starting hydralazine. She had no previous history of liver disease and was known to have normal serum aminotransferase and alkaline phosphatase levels. Abdominal CT scans and magnetic resonance cholangiopancreatography were normal and “no other laboratory evidence of cholestatic jaundice was found.” Serum bilirubin levels continued to rise (Table). Hydralazine was suspected as the cause of the liver injury and, indeed, serum enzyme elevations and bilirubin began to fall when it was stopped. Three months later serum bilirubin and alkaline phosphatase had fallen to baseline values.

#### Key Points

Medication: | Hydralazine
Pattern: | Cholestatic (R=1.7)
Severity: | Moderate (3+; jaundice and hospitalization)
Latency: | 10 weeks according to figure, 5 months according to text
Recovery: | 9 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | Pre | 20 | 175 | 0.8 | Hemodialysis
5 days | 0 | 25 | 180 | 0.5
Hydralazine (75 mg three times daily) started
10 weeks | 0 | 210 | 820 | 3.5 | Admitted for jaundice
11 weeks | 0 | 110 | 740 | 4.1 | Ultrasound normal
12 weeks | 0 | 100 | 760 | 6.2 | MRCP normal
Hydralazine stopped
13 weeks | 1 week | 50 | 640 | 2.1
15 weeks | 3 weeks | 50 | 390 | 1.1
18 weeks | 6 weeks | 30 | 210 | 0.6
21 weeks | 9 weeks | 20 | 120 | 0.5
Normal Values | | <40 | <130 | <1.2

*Some values estimated from figures 1 and 2.

#### Comment

The onset, clinical features, course and prompt improvement with stopping therapy are typical of hydralazine induced liver injury presenting after several months of therapy. Typically, cases with a longer latency period are associated with a hepatocellular pattern of serum enzyme elevations, autoantibodies and often present insidiously with fatigue rather than abrupt onset of fever, rash and jaundice. In this case report, the injury pattern was cholestatic and results of autoantibody testing and immunoglobulin levels were not provided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hydralazine – Generic, Apresoline®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hydralazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hydralazine | 86-54-4 | C8-H8-N4 | Hydralazine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 24 March 2018

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 655-6. (Expert review of hepatotoxicity published in 1999 mentions that more than 50 cases of hepatic injury due to hydralazine had been reported, rates being ~0.5%, usually arising within a few weeks, hepatocellular and accompanied by fever and eosinophilia, rare fatal instances have occurred).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hydralazine hepatotoxicity, mentions that hydralazine hepatotoxicity is extremely variable manifesting itself with hepatocellular, cholestatic, hypersensitivity, or autoimmune features).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics).
Jori GP, Peschile C. Hydralazine disease associated with transient granulomas in the liver. A case report. Gastroenterology 1973; 64: 1163-7. (52 year old woman developed fever and arthralgias 6 months after starting hydralazine with 10% eosinophilia, bilirubin 1.2 mg/dL, ALT 85 U/L, Alk P 3 times ULN, granulomas on biopsy, resolving within 6 weeks of stopping as proven by repeat liver biopsy). 4706137
Perry HM. Late toxicity to hydralazine resembling systemic lupus erythematosus or rheumatoid arthritis. Am J Med 1973; 54: 58-72. (Among 371 patients treated with hydralazine for 2 months to 20 years, late toxic effects developed in 12% resembling lupus or rheumatoid arthritis, clinical hepatitis in 2; almost all were ANA positive and all ultimately resolved after stopping). 4581906
Irias JJ. Hydralazine-induced lupus erythematosus-like syndrome. Am J Dis Child 1975; 129: 862-4. (9 year old girl developed arthralgias, fever, splenomegaly and ANA-positivity with normal serum enzymes and no jaundice 9 months after starting hydralazine; symptoms resolved within 1 and serology within 11 months of stopping). 50009
Knoblauch M, Cueni B, Spycher M, Schmid M. [Dihydralazine-induced acute hepatitis with IgM deficiency]. Schweiz Med Wochenschr 1977; 107: 651-6. German. (Two patients, one man and one woman both with IgM deficiency, developed elevations in bilirubin [1.9 and 12.7 mg/dL], ALT [135 and 530 U/L] and Alk P [1-2 times ULN] 6 months and two weeks after starting hydralazine, and both had more rapid recurrence on restarting). 867010
Bartoli E, Massarelli G, Solinas A, Faedda R, Chiandussi L. Acute hepatitis with bridging necrosis due to hydralazine intake. Report of a case. Arch Intern Med 1979; 139: 698-9. (59 year old woman developed abdominal pain and nausea within days of starting hydralazine [bilirubin rising from 1.3 to 8.9 mg/dL, ALT to 150 U/L], improving upon stopping and more severe recurrence on restarting; biopsy showed acute hepatitis with bridging hepatic necrosis, and follow up biopsy on methyldopa was markedly improved). 443977
Itoh S, Yamaba Y, Ichinoe A, Tsukada Y. Hydralazine-induced liver injury. Dig Dis Sci 1980; 25: 884-7. (68 year old man developed jaundice and fever, 3 years after starting hydralazine [bilirubin 8.1 mg/dL, ALT >300 U/L, Alk P 297 U/L], resolving rapidly on stopping, recurring within 2 weeks of rechallenge; case documented with four liver biopsies). 7438960
Barnett DB, Hudson SA, Golightly PW. Hydralazine-induced hepatitis? Br Med J 1980; 280: 1165-6. (37 year old woman developed nausea 2 weeks after starting hydralazine; restarting led to rise in ALT [11 to 504 U/L] and Alk P [153 to 1077 U/L] within 3 days without jaundice, and with rapid resolution on stopping). 7388447
Mölleken K, Rüger K. [Rare liver damage caused by antihypertensive and anti-arrhythmic agents]. Z Gesamte Inn Med 1980; 35: 296-9. German. (33 year old developed abdominal pain, weakness and jaundice 3-4 weeks after starting dihydralazine [bilirubin 5.7 mg/dL, ALT 295 U/L, Alk P 58, eosinophils 2%], resolving within 3 weeks of stopping). 7405322
Forster HS. Hepatitis from hydralazine. N Engl J Med 1980; 302: 1362. (37 year old man developed malaise 6 months after starting hydralazine [bilirubin normal, ALT 207 U/L, slight Alk P elevation, ANA-positivity], improving on stopping but recurrence of fever, rash and eosinophilia within hours of rechallenge). 7374684
Itoh S, Ichinoe A, Tsukada Y, Itoh Y. Hydralazine-induced hepatitis. Hepatogastroenterology 1981; 28: 13-6. (Three patients, 2 women, 1 man, ages 51-59 years, developed jaundice after 2, 10 and 24 months of hydralazine therapy with submassive necrosis on liver biopsy; resolving slowly). 7216134
Stewart GW, Peart WS, Boylston AW. Obstructive jaundice, pancytopenia and hydralazine. Lancet 1981; 8231: 1207. (63 year old man developed fever and abdominal pain 10 days after starting hydralazine [peak bilirubin 3.8 mg/dL, Alk P 1470 U/L, AST 257 U/L], resolving within two weeks of stopping). 6112544
Mansilla-Tinoco R, Harland SJ, Ryan PJ, Bernstein RM, Dollery CT, Hughes GRV, Bulpitt CJ, et al. Hydralazine antinuclear antibodies and the lupus syndrome. Br Med J 1982; 284: 936-9. (Among 221 patients treated with hydralazine, 60% developed ANA-positivity arising after 2-6 months, lower rate in blacks and rapid acetylators; 7 [3%] developed lupus-like syndrome). 6802356
Pariente EA, Pessayre D, Bernuau J, Degott C, Benhamou JP. Dihydralazine hepatitis: report of a case and review of the literature. Digestion 1983; 27: 47-52. (50 year old developed jaundice 3 months after starting dihydralazine [bilirubin 12.3 mg/dL, AST 68 times ULN, Alk P 1.5 times ULN], and had a severe recurrence upon restarting). 6884586
Roschlau G. [Dihydralazine-induced hepatitis with bridging necrosis. A clinico-pathologic survey of 20 cases]. Zentralbl Allg Pathol 1983; 127: 385-93. German. (20 cases of dihydralazine liver injury, with abrupt onset and jaundice arising at 2-8 weeks or with more insidious onset after 4-12 months; bridging necrosis frequent on liver biopsy; relapse occurs with reexposure with either form). 6880446
Rice D, Burdick CO. Granulomatous hepatitis from hydralazine therapy. Arch Intern Med 1983; 143: 1077. (51 year old woman developed fever and nausea 10 days after starting hydralazine [bilirubin 5.8 mg/dL, ALT 574 U/L, Alk P 212 U/L], biopsy showing granulomas, resolving within a month of stopping). 6679226
Myers JI, Augur NA. Hydralazine-induced cholangitis. Gastroenterology 1984; 87: 1185-8. (59 year old woman developed fever and right upper quadrant pain 8 days after starting hydralazine [bilirubin 5.2 mg/dL, AST 141 U/L, Alk P 540 U/L], with rapid recurrence after inadvertent rechallenge, rapid recovery: Case 1). 6479540
Reinhardt M, Machnik G, Krombholz B, Jahn G. [The so-called dihydralazine hepatitis. A contribution to the pathogenesis]. Dtsch Z Verdau Stoffwechselkr 1985; 45: 283-94. (14 cases of dihydralazine liver injury, 12 women and 2 men; ages 31-84 years, injury arising 1-10 weeks after starting, resolving in all after stopping, liver biopsy usually showing bridging necrosis and two showing fibrosis). 4092653
Kunze KD, Porst H, Tschöpel L. [Morphology and pathogenesis of liver injury produced by dihydralazine, propranolol and ketophenylbutazone]. Zentralbl Allg Pathol 1985; 130: 509-18. (Results of lymphocyte stimulation tests in 28 cases of drug induced liver injury; positive in 18 cases of dihydralazine hepatotoxicity which were also characterized by bridging necrosis and cholangitis on liver biopsy). 3841742
Hod M, Friedman S, Schoenfeld A, Theodor E, Ovadia J. Hydralazine-induced hepatitis in pregnancy. Int J Fertil. 1986; 31: 352-5. (Among 38 women given hydralazine during pregnancy, 5 developed right upper quadrant pain 2-4 weeks after starting [bilirubin 1.5-2.1 mg/dL, AST 280-314 U/L, decrease in platelet counts], resolving within 2 days of Caesarian section and stopping hydralazine, making it unclear whether the HELPP syndrome or drug induced liver injury was the cause). 2898436
Machnik G, Bergert A, Justus J, Kunze P, Müller R, Reinhardt M, Schulz H, et al. [Drug-induced hepatitis after dihydralazine treatment with fatal consequences]. Zentralbl Allg Pathol 1988; 134: 167-77. German. (3 cases of dihydralazine induced liver injury in 60-79 year old hypertensive patients, arising 1-12 months after starting dihydralazine [bilirubin 12.4, 18.1 and 8.3 mg/dL, ALT 5340, 392 and 102 U/L, Alk P 224, 277 and 138 U/L], liver biopsies showing bridging or confluent necrosis, all three dying of complications of hepatic injury). 3420978
Roschlau G, Hass S, Schmehl V. [Chronic drug-induced hepatitis caused by dihydralazine]. Dtsch Z Verdau Stoffwechselkr 1988; 48: 41-6. German. (2 cases; 52 year old woman found to have elevations in ALT and bilirubin 3 years after starting dihydralazine, with biopsy showing chronic hepatitis with bridging fibrosis; 74 year old woman developed jaundice after 2 years of dihydralazine therapy, with biopsy showing chronic hepatitis and bridging fibrosis; symptoms and laboratory abnormalities resolved completely with stopping therapy). 3371237
Shaefer MS, Markin RS, Wood RP, Shaw BW Jr. Hydralazine-induced cholestatic jaundice following liver transplantation. Transplantation 1989; 47: 203-4. (16 year old boy treated with iv hydralazine for hypertension 1-3 days after liver transplantation developed flushing, rash and rise in bilirubin levels, but role of hydralazine versus other factors was unclear). 2643228
Bourdi M, Larrey D, Nataf J, Bernuau J, Pessayre D, Iwasaki M, Guengerich FP, et al. Anti-liver endoplasmic reticulum autoantibodies are directed against human cytochrome P-450IA2. A specific marker of dihydralazine-induced hepatitis. J Clin Invest 1990; 85: 1967-73. (Serum from 5 patients with dihydralazine induced liver injury arising 2-6 months after starting therapy were found to have antibodies to human CYP 1A2, which inhibited its enzymatic activity). 2347920
Roschlau G, Baumgarten R, Fengler JD. [Dihydralazine hepatitis. Morphologic and clinical criteria for diagnosis]. Zentralbl Allg Pathol 1990; 136: 127-34. German. (70 cases of dihydralazine induced hepatitis with confluent or bridging necrosis found between 1981 and 1985; more frequent in women than men). 2327183
Stumpf JL. Fatal hepatotoxicity induced by hydralazine or labetalol. Pharmaco-therapy 1991; 11: 415-8. (73 year old man developed jaundice 5 months after starting hydralazine and 2 months after starting labetalol [bilirubin 26 mg/dL, ALT 4590 U/L, Alk P 346 U/L], with progressive hepatic failure and death 11 days later). 1745625
Bourdi M, Gautier JC, Mircheva J, Larrey D, Guillouzo A, Andre C, Belloc C, et al. Anti-liver microsomes autoantibodies and dihydralazine-induced hepatitis: specificity of autoantibodies and inductive capacity of the drug. Mol Pharmacol 1992; 42: 280-5. (Analysis of antibodies from 6 patients with dihydralazine induced liver injury showed reactivity to CYP 1A2 and not 1A1; antibodies inhibited enzyme activity; anti-CYP1A2 could also be induced in rats given dihydralazine). 1513326
Tameda Y, Hamada M, Takase K, Nakano T, Kosaka Y. Fulminant hepatic failure caused by ecarazine hydrochloride (a hydralazine derivative). Hepatology 1996; 23: 465-70. (Among 16 patients with acute liver failure possibly due to medications, 7 had received ecarazine [a derivative of hydralazine] for 11 days to more than a year with jaundice and high ALT levels and progression to hepatic failure, despite stopping the medication; autoantibodies frequent as was massive or bridging necrosis; 4 died). 8617425
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to hydralazine). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one case was attributed to hydralazine). 18955056
Hassan A, Hammad R, Cucco R, Niranjan S. Hydralazine-induced cholestatic hepatitis. Am J Ther 2009; 16: 371-3. (63 year old developed abdominal pain and jaundice ~3 months after starting hydralazine [peak bilirubin 6.5 mg/dL, ALT ~400 U/L, Alk P ~825 U/L], resolving within 9 weeks of stopping: Case 2). 19092641
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one of which was attributed to hydralazine). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to hydralazine). 20648003
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, et al. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Retrospective analysis of 261 cases of autoimmune hepatitis, 24 [9%] of which were due to a medication; 11 nitrofurantoin and 11 minocycline, but none to hydralazine). 20512992
Fleming P, Marik PE. The DRESS syndrome: the great clinical mimicker. Pharmacotherapy 2011; 31: 332. (44 year old woman with a hemorrhagic stroke and sepsis developed fever, exfoliative rash, facial edema and eosinophilia 3 weeks after starting hydralazine, but also while receiving vancomycin making attribution difficult). 21361742
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to hydralazine). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 4 [2%] to antihypertensive agents [methyldopa, enalapril and verapamil], but none to hydralazine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4.3%] were attributed to antihypertensives including 8 to hydralazine and 11 to methyldopa). 25754159
deLemos AS, Foureau DM, Jacobs C, Ahrens W, Russo MW, Bonkovsky HL. Drug-induced liver injury with autoimmune features. Semin Liver Dis 2014; 34: 194-204. (Review of drug induced liver injury with autoimmune features includes a case of hydralazine jaundice arising 3 weeks after stopping a 10 week course of hydralazine [bilirubin 19.8 mg/dL, ALT 1005 U/L, Alk P 239 U/L, INR 2.0, ANA 1:160], with progressive liver injury necessitating liver transplantation 2 months later). 24879983
Alansari A, Quiel L, Boma N. A one-two punch: hydralazine-induced liver injury in a recovering ischemic hepatitis. Am J Ther 2016; 23: e1094-5. (77 year old woman with cardiomyopathy and atrial fibrillation had elevations in serum ALT [391 U/L] which improved with control of heart rate but worsened again 4 days after starting hydralazine [peak ALT 359 U/L], ultimately resolving 1 month after stopping). 25423497
Harati H, Rahmani M, Taghizadeh S. Acute cholestatic liver injury from hydralazine intake. Am J Ther 2016; 23: e1211-4. (75 year old African American woman developed jaundice 10 weeks after starting hydralazine [bilirubin 22.0 mg/dL, ALT 242 U/L, Alk P 166 U/L, INR 1.23, ANA negative], that improved with prednisone therapy and stopping hydralazine, all tests being normal 5 weeks later). 26291593
de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, et al.; Drug-Induced Liver Injury Network. Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol 2017; 15: 103-12. (Among 7 patients with hydralazine induced liver injury enrolled in a US prospective database [Chalasani 2015], 5 were women, 4 white and 3 black, ages 42 to 72 years, latency to onset of 2 weeks to 7 months, 5 with jaundice [bilirubin 0.3 to 29.7 mg/dL, ALT 132 to 2018 U/L, Alk P 188 to 607 U/L] and 1 with acute liver failure requiring liver transplantation [deLemos 2014]; 3 had autoimmune features, but ANA levels tended to decrease with recovery). 27311619

## OTHER REFERENCE LINKS

1. Recent References on Hydralazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(hydralazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/4/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Hydralazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=hydralazine)